# Moexipril

## OVERVIEW

### Introduction

Moexipril is an angiotensin-converting enzyme (ACE) inhibitor which is used in the therapy of hypertension. Moexipril is associated with a low rate of transient serum aminotransferase elevations, but has yet to be linked to instances of acute liver injury.

### Background

Moexipril (moe ex' i pril) is an ACE inhibitor which is approved for use alone and in combination with other agents in the therapy of hypertension. Like other ACE inhibitors, moexipril inhibits the conversion of angiotensin I, a relatively inactive molecule, to angiotensin II which is the major mediator of vasoconstriction and volume expansion induced by the renin-angiotensin system. Other host enzymes besides that which converts angiotensin I to II may be inhibited as well, which may account for some of the side effects of the ACE inhibitors. Moexipril was approved for use in the United States in 1991 and is available in 7.5 and 15 mg tablets in several generic forms and under the trade name Univasc. The typical daily dose in adults is 7.5 to 30 mg in one or two divided doses which is administered long term. Moexipril is also available in fixed dose combinations with hydrochlorothiazide (Uniretic and generics). Common side effects include dizziness, fatigue, headache, cough, gastrointestinal upset and skin rash.

### Hepatotoxicity

Moexipril, like other ACE inhibitors, is associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo therapy. These elevations are transient and rarely require dose modification. Clinically apparent cases of acute liver injury due to moexipril have yet to be published. Most ACE inhibitors have been associated with rare instances of clinically apparent liver injury, which typically arises 2 to 12 weeks after starting therapy and is marked by a cholestatic pattern of injury which can be severe and prolonged. Immunoallergic manifestations (rash, fever, eosinophilia) are infrequent and most patients do not develop autoantibodies. Rare instances of severe acute hepatocellular injury, sometimes arising 1 to 4 years after starting ACE inhibitors, have been described, but not in association with moexipril. Nevertheless, the product label mentions the possibility of drug induced liver injury.

Likelihood score: E* (unlikely but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated ACE inhibitors including moexipril is not known. Moexipril is hydrolyzed in the liver to the active metabolite moexiprilat, and idiosyncratic liver injury might be induced by a minor metabolite.

### Outcome and Management

There have been too few instances of moexipril associated liver injury described to provide an overall description of its course and outcome. Most instances of acute liver injury reported with ACE inhibitors have been self limited, but there have been rare reports of acute liver failure due to captopril, enalapril, lisinopril and benazepril and several reports of cholestatic hepatitis due to ACE inhibitors leading to prolonged jaundice and vanishing bile duct syndrome. Although cross sensitivity to liver injury has not always been shown, patients with severe acute liver injury due to an ACE inhibitor should avoid use of other drugs belonging to this class of agents.

References to the safety and potential hepatotoxicity of moexipril are given in the Overview section on the Angiotensin-Converting Enzyme (ACE) Inhibitors.

Drug Class: Antihypertensive Agents, Angiotensin-Converting Enzyme Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Moexipril – Generic, Univasc®

DRUG CLASS

Angiotensin-Converting Enzyme Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Moexipril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Moexipril | 103775-10-6 | C27-H34-N2-O7 | Moexipril Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Moexipril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Moexipril/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Moexipril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Moexipril)